# Sarilumab

## OVERVIEW

### Introduction

Sarilumab is a human monoclonal IgG1 antibody to the interleukin-6 (IL-6) receptor which is used in the therapy of rheumatoid arthritis and other autoinflammatory conditions. Sarilumab commonly causes mild serum aminotransferase elevations which are usually short lived and asymptomatic and has also been linked to rare instances of clinically apparent liver injury with jaundice.

### Background

Sarilumab (sar il' ue mab) is a human IgG1 monoclonal antibody to the IL-6 receptor that is used largely as therapy of refractory rheumatoid arthritis. Sarilumab binds to both soluble and membrane bound IL-6 receptors and blocks IL-6 signaling. IL-6 is a key proinflammatory cytokine that mediates a wide spectrum of biologic activities including activation of T cells, differentiation of B cells, induction of acute phase reactants, proliferation of fibroblasts, and damage to cartilage and joints. IL-6 levels are elevated in patients with active rheumatoid arthritis. In controlled trials and open label studies, sarilumab therapy led to improvements in symptoms and laboratory abnormalities in patients with rheumatoid arthritis who had an inadequate response to other disease modifying antirheumatic drugs (DMARDs). Sarilumab was approved for use in the United States in 2017 for refractory rheumatoid arthritis. It is considered a DMARD, in that it improves signs and symptoms of disease and decreases cartilage and tissue destruction. Because IL-6 is found in high levels in patients with severe COVID-19 pneumonia, sarilumab was evaluated as therapy of the hyperinflammatory state in hospitalized patients with respiratory compromise. In prospective controlled trials, however, sarilumab therapy was associated with minimal or no improvement in clinical status or survival. Sarilumab is under evaluation in other inflammatory rheumatic diseases as well as other inflammatory autoimmune conditions, but has not been approved for these uses. For therapy of rheumatoid arthritis, sarilumab is given in doses of 200 mg by subcutaneous injection every 2 weeks either alone (monotherapy) or in combination with other conventional DMARDs. Sarilumab is available in single dose prefilled syringes of 150 and 200 mg in 1.14 mL under the brand name Kevzara. The most frequent side effects are neutropenia, upper respiratory symptoms, urinary tract infections headache, infusion reactions and hypertension. Rare, potentially serious adverse events include severe neutropenia, serious infections, reactivation of tuberculosis, gastrointestinal perforation and hypersensitivity reactions.

### Hepatotoxicity

In registration trials, serum aminotransferase elevations occurred in a higher proportion of patients receiving sarilumab than placebo. Mean levels of ALT and AST increased within 2 weeks of starting the monoclonal antibody and remained constant thereafter until stopping. At the same time, total bilirubin values increased slightly, while alkaline phosphatase values decreased. ALT elevations above 3 times the ULN occurred in 4% to 5% of patients receiving sarilumab (150 or 200 mg twice weekly) vs 1% of those receiving placebo. Despite the frequent elevations in liver tests, there were no instances of clinically apparent liver injury attributable to sarilumab therapy and most aminotransferase elevations were self-limited and without symptoms. Thus, sarilumab has not been linked to instances of clinically apparent liver injury.

Sarilumab is an immunosuppressive agent and is suspected to predispose to serious infections including reactivation of tuberculosis and hepatitis. Nevertheless, the frequency of serious infections in the controlled trials of sarilumab was similar to that with placebo therapy and there were no reports of tuberculosis or hepatitis B.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Sarilumab is a monoclonal antibody and has minimal hepatic metabolism. The mechanism by which it might cause liver injury is unknown, but may be the result of its effects on the immune system or on the IL-6 pathway which is important in liver regeneration. A similar pattern of enzyme elevations occurs with tocilizumab, another monoclonal antibody to the IL-6 receptor used to treat rheumatoid arthritis.

### Outcome and Management

The serum aminotransferase elevations associated with sarilumab therapy are generally mild and self-limited, improving spontaneously despite continuing therapy and resolving completely upon stopping. On the other hand, there is no reason to suspect that there may be cross sensitivity to hepatic injury between sarilumab and other immune modulating biologic agents or anti-IL1 blockers such as anakinra, canakinumab and rilonacept and the IL-6 antagonists siltuximab and tocilizumab.

Drug Class: Antirheumatic Agents, COVID-19 Drugs

Other Drugs in the Subclass, Interleukin Receptor Antagonists: Anakinra, Canakinumab, Rilonacept, Tocilizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sarilumab – Kevzara®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sarilumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Sarilumab | 1189541-98-7 | Monoclonal Antibody | No Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 23 March 2021

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999, long before the availability of sarilumab and other monoclonal antibodies).
Krensky AM, Bennett WM, Vincenti F. Immunosuppressants, tolerogens, and immunostimulants. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1005-29. (Textbook of pharmacology and therapeutics).
Carroll MB. (2011). The impact of biologic response modifiers on hepatitis B virus infection. Expert Opin Biol Ther. (Review of reactivation of hepatitis B by biologic response modifiers; sarilumab is not mentioned).
Bannwarth B, Richez C. (2011). Clinical safety of tocilizumab in rheumatoid arthritis. Expert Opin Drug Saf. (Review of the adverse events reported in clinical trials of tocilizumab in rheumatoid arthritis; among 3689 patients with normal ALT levels before treatment, 10.3% had ALT elevations >3 times ULN and 2.4% above 5 times ULN, but there were no cases of clinical apparent liver injury).
Hiura M, Abe S, Tabaru A, Shimajiri S, Hanami K, Saito K, Tanaka Y, et al. (2011). Case of severe liver damage after the induction of tocilizumab therapy for rheumatoid vasculitis. Hepatol Res. (71 year old man with refractory rheumatoid arthritis and vasculitis developed mild serum enzyme elevations during 3 months of tocilizumab therapy [bilirubin 1.3 mg/dL, ALT 67 U/L, Alk P 380 U/L, platelets 93,000/μL], later developing ascites, and hepatic failure, autopsy showing hepatic atrophy and little fibrosis).
Gabay C, Emery P, van Vollenhoven R, Dikranian A, Alten R, Pavelka K, Klearman M, et al., ADACTA Study Investigators. (2013). Tocilizumab monotherapy versus adalimumab monotherapy for treatment of rheumatoid arthritis (ADACTA): a randomised, double-blind, controlled phase 4 trial. Lancet. (Controlled trial comparing 24 week courses of 2 monoclonal antibody therapies in 326 patients with rheumatoid arthritis; ALT elevations above 2.5 times ULN occurred in 6% on tocilizumab vs 1.9% on adalimumab, but there were no serious adverse events attributed to liver injury).
Alfreijat M, Habibi M, Bhatia P, Bhatia A. (2013). Severe hepatitis associated with tocilizumab in a patient with rheumatoid arthritis. Rheumatology (Oxford). (62 year old man with rheumatoid arthritis developed jaundice 1 week after a 3rd monthly injection of tocilizumab [bilirubin 10.5, ALT 2296, Alk P not given], resolving within 10 weeks on prednisone; accompanied by mild pancreatitis).
Drepper M, Rubbia-Brandt L, Spahr L. (2013). Tocilizumab-induced acute liver injury in adult onset Still's disease. Case Reports Hepatol. (18 year old woman with Still disease developed jaundice 6 months after starting tocilizumab [bilirubin 3.6 mg/dL, ALT 2628 U/L, Alk P 110 U/L, INR 1.21], with liver biopsy showing centrolobular necrosis, and resolving within 1 month of stopping).
Huizinga TW, Fleischmann RM, Jasson M, Radin AR, van Adelsberg J, Fiore S, Huang X, et al. (2014). Sarilumab, a fully human monoclonal antibody against IL-6Rα in patients with rheumatoid arthritis and an inadequate response to methotrexate: efficacy and safety results from the randomised SARIL-RA-MOBILITY Part A trial. Ann Rheum Dis. (Among 306 patients with rheumatoid arthritis and an inadequate response to methotrexate who were treated with 1 of 5 regimens of sarilumab or placebo for 12 weeks, highest response rates occurred with the highest doses and adverse events included infections [20-26% vs 14%], neutropenia [2-6% vs 0] and ALT elevations [4-6% vs 0], most of which resolved spontaneously and there were no hepatic severe adverse events).
Genovese MC, Fleischmann R, Kivitz AJ, Rell-Bakalarska M, Martincova R, Fiore S, Rohane P, et al. (2015). Sarilumab plus methotrexate in patients with active rheumatoid arthritis and inadequate response to methotrexate: results of a phase III study. Arthritis Rheumatol. (Among 1282 patients with rheumatoid arthritis and inadequate responses to methotrexate treated with intravenous sarilumab [150 or 200 mg] or placebo every 2 weeks for 52 weeks, clinical response rates were greater with sarilumab [58-66% vs 33%] as were rates of adverse events including neutropenia, infections, injection site reactions and ALT elevations above 3 times ULN [8.0-9.5% vs 2.1%], but there were no episodes of clinically apparent liver injury).
Sieper J, Braun J, Kay J, Badalamenti S, Radin AR, Jiao L, Fiore S, et al. (2015). Sarilumab for the treatment of ankylosing spondylitis: results of a Phase II, randomised, double-blind, placebo-controlled study (ALIGN). Ann Rheum Dis. (Among 301 patients with ankylosing spondylitis treated with one of 5 dose regimens of sarilumab or placebo for 12 weeks, there were no differences in clinical response rates among treatment groups, and adverse events included neutropenia, infections and ALT elevations).
Burmester GR, Lin Y, Patel R, van Adelsberg J, Mangan EK, Graham NM, van Hoogstraten H, et al. (2017). Efficacy and safety of sarilumab monotherapy versus adalimumab monotherapy for the treatment of patients with active rheumatoid arthritis (MONARCH): a randomised, double-blind, parallel-group phase III trial. Ann Rheum Dis. (Among 363 patients with rheumatoid arthritis with an inadequate response to methotrexate treated with sarilumab vs adalimumab monotherapy, response rates were greater with sarilumab while adverse event rates were similar, overall rates being 64% vs 64%, neutropenia 13.6% vs 0.5% and ALT elevations 3.8% vs 3.8%).
Fleischmann R, van Adelsberg J, Lin Y, Castelar-Pinheiro GD, Brzezicki J, Hrycaj P, Graham NM, et al. (2017). Sarilumab and nonbiologic disease-modifying antirheumatic drugs in patients 2ith active rheumatoid arthritis and inadequate response or intolerance to tumor necrosis factor inhibitors. Arthritis Rheumatol. (Among 546 patients with rheumatoid arthritis and an inadequate response to conventional therapy who were treated with sarilumab [150 or 200 mg every 2 weeks] or placebo for an average of 34 weeks, clinical responses were greater with sarilumab [56-61% vs 34%] as were adverse events including neutropenia [13% vs 1%] and ALT elevations above 3 times ULN [2.2-4.3% vs 1.1%], but all resolved, only one requiring discontinuation).
Scott LJ. (2017). Sarilumab: First global approval. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of sarilumab shortly after its approval in the US for rheumatoid arthritis; no mention of ALT elevations or hepatotoxicity).
FDA safety review of elevations in liver associated enzymes during sarilumab therapy. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/761037Orig1s000MedR.pdf (Accessed July 31, 2017).
(2017). Sarilumab (Kevzara) for rheumatoid arthritis. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of sarilumab shortly after its approval for use in rheumatoid arthritis in the US mentions side effects of infections, neutropenia, ALT elevations [5%], and injection site reactions).
(2018). Drugs for rheumatoid arthritis. Med Lett Drugs Ther. (Concise review of the drugs approved for use in rheumatoid arthritis mentions two monoclonal antibodies to IL-6).
Genovese MC, van Adelsberg J, Fan C, Graham NMH, van Hoogstraten H, Parrino J, Mangan EK, Spindler A, et al., EXTEND study investigators. (2018). Two years of sarilumab in patients with rheumatoid arthritis and an inadequate response to MTX: safety, efficacy and radiographic outcomes. Rheumatology (Oxford). (Among 901 patients with rheumatoid arthritis who were enrolled in an extension trial of sarilumab beneficial effects were sustained for the duration of treatment, and ALT elevations continued to arise but were generally short lived and none were associated with jaundice and symptoms; elevations above 3 times ULN arose in 12%, were above 5 times ULN in 3.8% and were the reason for dose reductions in 3.6% of patients).
Fleischmann R, Genovese MC, Lin Y, St John G, van der Heijde D, Wang S, Gomez-Reino JJ, et al. (2020). Long-term safety of sarilumab in rheumatoid arthritis: an integrated analysis with up to 7 years' follow-up. Rheumatology (Oxford). (Analysis of pooled results from trials of sarilumab in rheumatoid arthritis with up to 7 years of exposure found ALT elevations above 3 times ULN in 6% on sarilumab monotherapy and 10% on combination therapy with another DMARD [usually methotrexate], abnormalities usually arising within the first 6 months of therapy, but none were associated with clinically apparent hepatitis).
Della-Torre E, Campochiaro C, Cavalli G, De Luca G, Napolitano A, La Marca S, Boffini N, et al., SARI-RAF Study Group. (2020). SARI-RAF Study Group members. Interleukin-6 blockade with sarilumab in severe COVID-19 pneumonia with systemic hyperinflammation: an open-label cohort study. Ann Rheum Dis. (28 patients with severe COVID-19 pneumonia and elevated inflammatory markers in serum were treated with intravenous sarilumab [400 mg] and were followed for 28 days, at which point comparison to a matched concurrently follow group found no difference in clinical improvement [61% vs 64%] or death [7% vs 18%], but higher rates of liver enzyme elevations [14% vs none]).
Gremese E, Cingolani A, Bosello SL, Alivernini S, Tolusso B, Perniola S, Landi F, et al., GEMELLI AGAINST COVID-19 Group. (2020). Sarilumab use in severe SARS-CoV-2 pneumonia. EClinicalMedicine. (Among 53 patients with severe COVID-19 pneumonia treated with sarilumab [400 mg iv] in an uncontrolled open-label trial, the mortality rate was 5.7% and there were no serious adverse events).
REMAP-CAP Investigators, Gordon AC, Mouncey PR, Al-Beidh F, Rowan KM, Nichol AD, Arabi YM, Annane D, et al. Interleukin-6 receptor antagonists in critically ill patients with Covid-19. N Engl J Med 2021: NEJMoa2100433. (Among 366 patients receiving tocilizumab, 48 sarilumab and 412 standard of care therapy for severe COVID-19 pneumonia enrolled in a prospective, multinational adaptive clinical trial, organ-support free days were greater and mortality less in those receiving anti-IL6 therapy; there were no serious adverse events associated with sarilumab but other specific results were not provided).
Lescure FX, Honda H, Fowler RA, Lazar JS, Shi G, Wung P, Patel N, et al.; Sarilumab COVID-19 Global Study Group. Sarilumab in patients admitted to hospital with severe or critical COVID-19: a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Respir Med 2021: S2213-2600(21)00099-0. (Among 420 patients with severe COVID-19 pneumonia treated with sarilumab [200 or 400 mg iv] or placebo, there were no differences in the median time to improvement or 29 day survival and ALT elevations arose in 19% of placebo vs 30-32% of sarilumab treated subjects; no mention of clinically apparent liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Sarilumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sarilumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Sarilumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sarilumab)